# Istradefylline

## OVERVIEW

### Introduction

Istradefylline is an adenosine receptor antagonist that is used as adjunctive therapy to levodopa/carbidopa in patients with Parkinson disease experiencing difficulty with “off” episodes when motor symptoms breakthrough on treatment. Istradefylline has been associated with a low rate of serum enzyme elevations during therapy, but has not been linked to cases of clinically apparent liver injury with jaundice.

### Background

Istradefylline (is” tra def’ i lin) is an adenosine [A_2A_] receptor antagonist that acts independently of dopaminergic pathways, reducing the overactive striatopallidal output that results in increased GABAergic inhibitory activity. Levodopa/carbidopa is the mainstay of therapy of Parkinson disease increasing brain dopamine levels and typically alleviating the motor symptoms of Parkinson disease for 5 to 6 hours. After the first 2 to 5 years of therapy, however, the duration of benefit becomes shorter (wearing off effect), and patients develop fluctuations between mobility and immobility (on-off effect). Patients with Parkinson disease and motor complications have been found to have overactive striatopallidal output. For this reason, istradefylline was assessed in animal models where it was found to decrease striatopallidal output and the resultant excessive GABAergic activity. In clinical trials, istradefylline when given in combination with levodopa/carbidopa decreased the wake-time “off” episodes in patients with Parkinson disease. Initially, applications for approval of istradefylline were rejected by the FDA because of its modest effects; it was, however, approved in Japan. In 2019, based upon further studies and demonstration of safety, istradefylline was approved in the United States for use as adjunctive therapy to levodopa for adults with Parkinson disease who were experiencing “off” episodes. Istradefylline is currently available as tablets of 20 and 40 mg under the brand name Nourianz. The recommended dose is 20-40 mg once daily. While istradefylline may improve control of symptoms, there is no evidence that it slows the progression of Parkinson disease. Common side effects include dyskinesia, dizziness, constipation, nausea, and insomnia. Less common but potentially severe adverse events include hallucinations, psychotic and compulsive behaviors, hypersexuality, and severe dyskinesia.

### Hepatotoxicity

In prelicensure controlled trials, serum ALT elevations occurred in 4% to 11% of istradefylline-treated subjects compared to 5% to 6% of placebo recipients, most of whom were taking multiple other agents for Parkinson disease. The elevations were usually mild-to-moderate in severity, asymptomatic and self-limited in course. ALT elevations above 3 times the ULN occurred in less than 1% recipients and rarely led to discontinuation. None of the aminotransferase elevations were accompanied by symptoms or jaundice. In preregistration clinical trials and subsequently with its more widespread use, istradefylline has not been linked to instances of clinically apparent liver injury. It has, however, had limited clinical use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Istradefylline is a specific antagonist of the A_2A_ adenosine receptors and a first-in-class agent. The mechanism by which it might cause liver injury is not known. It is metabolized in the liver, largely via CYP 3A4 and 1A1 and is sensitive to drug-drug interactions with strong inducers or inhibitors of the CYP 3A4 microsomal enzyme. Thus, hepatotoxicity might be caused by metabolic idiosyncrasy that produces a toxic or immunogenic byproduct of metabolism.

### Outcome and Management

Istradefylline has been linked to mild-to-moderate serum enzyme elevations during therapy. Discontinuation for serum enzyme elevations is rarely necessary, but should be done if the elevations are accompanied by symptoms or jaundice or for ALT elevations of more than 5 times the upper limit of normal (ULN). There is no information on cross sensitivity to liver injury between istradefylline and other agents used in the therapy of Parkinson disease.

Drug Class: Parkinson Disease Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Istradefylline – Nourianz®

DRUG CLASS

Central Nervous System Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Istradefylline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Istradefylline | 155270-99-8 | C20-H24-N4-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 18 October 2021

Abbreviations used: COMT, catechol O-methyltransferase; MAO, monoamine oxidase.

Roberson ED. Parkinson Disease. Treatment of central nervous system degenerative disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 328-333. (Textbook of pharmacology and therapeutics; istradefylline and adenosine receptor antagonists are not discussed).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/022075Orig1s000MedR.pdf (FDA website including product label and clinical review of data submitted in support of approval of istradefylline mentions that therapy is associated with a slight increase rate of ALT elevations compared to placebo [6.9% overall vs 5.9%], but elevations above 3 times ULN were rare and there were no cases with concurrent bilirubin elevations).
Hauser RA, Hubble JP, Truong DD. (2003). Istradefylline US-001 Study Group. Randomized trial of the adenosine A(2A) receptor antagonist istradefylline in advanced PD. Neurology. (Among 83 patients with Parkinson disease and motor fluctuations despite optimal conventional therapy using levodopa who were treated with istradefylline [20 or 40 mg] or placebo daily for 12 weeks, “off” time decreased with istradefylline [-7.1% vs +2.2%], while adverse events included nausea [28% vs 7%], dyskinesia [17% vs 14%], dizziness [13% vs 3%] and lipase elevations; no mention of ALT elevations or hepatotoxicity).
LeWitt PA, Guttman M, Tetrud JW, Tuite PJ, Mori A, Chaikin P, Sussman NM. (2008). 6002-US-005 Study Group. Adenosine A2A receptor antagonist istradefylline (KW-6002) reduces "off" time in Parkinson's disease: a double-blind, randomized, multicenter clinical trial (6002-US-005). Ann Neurol. (Among 196 patients with Parkinson disease and prominent wearing “off” episodes of motor fluctuations treated with istradefylline [40 mg] or placebo once daily for 12 weeks, there was a greater decrease in daily awake “off” time with istradefylline [-10.8% vs -4.0%], but adverse events were more frequent including dyskinesia [30% vs 15%] and serious adverse events [7.8% vs 1.5%], while “important differences were not observed between the two groups for clinical laboratory” results).
Stacy M, Silver D, Mendis T, Sutton J, Mori A, Chaikin P, Sussman NM. (2008). A 12-week, placebo-controlled study (6002-US-006) of istradefylline in Parkinson disease. Neurology. (Among 395 levodopa treated patients with Parkinson disease treated with istradefylline [20 or 60 mg] or placebo once daily for 12 weeks, daily wake “off’ time decreased more with istradefylline, and adverse events were generally mild and included dyskinesia, dizziness, headache, nausea, constipation and hallucinations, and “no clinically important differences were observed among the groups for changes in clinical laboratory assessments”; no mention of ALT elevations or hepatoxicity).
Fernandez HH, Greeley DR, Zweig RM, Wojcieszek J, Mori A, Sussman NM. (2010). 6002-US-051 Study Group. Istradefylline as monotherapy for Parkinson disease: results of the 6002-US-051 trial. Parkinsonism Relat Disord. (Among 196 patients with Parkinson disease not taking levodopa treated with istradefylline [40 mg] or placebo once daily for 12 weeks, symptom scores improved on istradefylline but the changes were not significantly greater than with placebo, while total adverse event rates were similar [63% vs 65%] as well as “potentially significant changes in laboratory values” [6.4% vs 6.1%]; no mention of ALT elevations or hepatotoxicity).
Mizuno Y, Hasegawa K, Kondo T, Kuno S, Yamamoto M, Japanese Istradefylline Study Group. (2010). Clinical efficacy of istradefylline (KW-6002) in Parkinson's disease: a randomized, controlled study. Mov Disord. (Among 363 Japanese patients with Parkinson disease and motor complications treated with istradefylline or placebo for 12 weeks, there were greater decreases in “off” time with istradefylline [-1.3 and -1.6 vs -0.7 hours], while overall adverse event rates were similar [59% vs 58%] including dyskinesia [7.4% vs 2.5%]; no mention of ALT elevations or hepatotoxicity).
Kondo T, Mizuno Y, Japanese Istradefylline Study Group. (2015). A long-term study of istradefylline safety and efficacy in patients with Parkinson disease. Clin Neuropharmacol. (Among 308 Japanese patients with Parkinson disease and motor complications treated with istradefylline or placebo for 52 weeks, istradefylline was associated with a decrease in off time compared to placebo that was sustained for the duration of treatment, while adverse events were similar, and “no clinically meaningful abnormalities were noted in laboratory parameters”).
Takahashi M, Fujita M, Asai N, Saki M, Mori A. (2018). Safety and effectiveness of istradefylline in patients with Parkinson's disease: interim analysis of a post-marketing surveillance study in Japan. Expert Opin Pharmacother. (Among 476 Japanese patients with Parkinson disease being treated with istradefylline who were followed in a postmarketing surveillance study, adverse events included dyskinesia in 5%, hallucinations [3.4%], somnolence [1.1%], and elevations in ALT [in only 1 subject: 0.2%]).
Istradefylline (Nourianz) for Parkinson's disease. (2020). Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of istradefylline as an adjunct to carbidopa/levodopa in adults with Parkinson disease who experience “off” episodes, mentions common adverse events of dyskinesia, constipation, dizziness, nausea, hallucinations, and insomnia but does not mention ALT elevations or hepatotoxicity).
Chen JF, Cunha RA. (2020). The belated US FDA approval of the adenosine A2A receptor antagonist istradefylline for treatment of Parkinson's disease. Purinergic Signal. (Review of the mechanism of action and rationale for use of adenosine A2A receptor antagonists, including istradefylline which was not approved based upon an initial FDA application in 2008 because of the relatively modest benefit in reducing “off” time in patients with Parkinson disease and motor complications; eventual approval was supported by consistent beneficial results in multiple clinical trials, substantial safety data in over 4000 patients, and results of long term studies showing modest but sustained improvement).
Drugs for Parkinson's disease. (2021). Med Lett Drugs Ther. (Concise review of current medications approved for use in Parkinson disease including levodopa/carbidopa, dopamine agonists, COMT inhibitors, MAO-B inhibitors, anticholinergics, and istradefylline, mentions hepatotoxicity of tolcapone but not of any other of the adjunctive therapies).
Hauser RA, Hattori N, Fernandez H, Isaacson SH, Mochizuki H, Rascol O, Stocchi F, et al. (2021). Efficacy of istradefylline, an adenosine A2A receptor antagonist, as adjunctive therapy to levodopa in Parkinson's disease: a pooled analysis of 8 phase 2b/3 trials. J Parkinsons Dis. (In a pooled analysis of 8 randomized placebo-controlled trials of istradefylline in 2719 patients with Parkinson disease and motor complications, changes in “off” time compared to placebo averaged 45 minutes per day with 20 mg and 49 minutes per day with 40 mg of istradefylline, while adverse event rates were similar in the 3 groups [71% and 70% vs 65%] except for dyskinesia [16% and 18% vs 10%], and “no clinically meaningful changes in laboratory parameters…were observed” in any group).

## OTHER REFERENCE LINKS

1 Recent References on Istradefylline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Istradefylline+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Istradefylline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Istradefylline)